# Miglustat

## OVERVIEW

### Introduction

Miglustat is an oral inhibitor of glucosylceramide synthase which is used in the therapy of type 1 Gaucher disease. Clinical experience with miglustat is limited, but it has not been linked to serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Miglustat (me' gloo stat) is a small molecule inhibitor of glucosylceramide synthase, the first and rate controlling step in the pathway of glycolipid synthesis. By inhibiting the pathway, lower levels of substrate are available, less is available for lysosomal degradation and less glycosylceramide accumulates. Miglustat was shown to decrease the intracellular accumulation of glycosylceramide, the major glycolipid that accumulates in Gaucher disease, in animal models of the genetic disease. In several randomized controlled trials, miglustat was shown to decrease spleen and liver volume and increase hemoglobin and platelet counts in patients with type 1 Gaucher disease. Miglustat was also able to maintain clinical benefit in patients who had been maintained on long term enzyme replacement therapy with glucocerebrosidase infusions (the lysosomal enzyme that is deficient in type 1 Gaucher disease). Miglustat was approved in the United States in 2003 as oral therapy of type 1 Gaucher Disease in patients who are not eligible for enzyme replacement therapy. Miglustat has also been evaluated in other lysosomal enzyme deficiencies and is approved in Europe, but not the United States as therapy of Niemann–Pick disease, type C. Miglustat is available in tablets of 100 mg under the brand name Zavesca. The usual dose regimen is 100 mg three times daily, but dose adjustments are needed for patients with significant side effects or renal impairment. Side effects are common and can be problematic including diarrhea, weight loss, gastrointestinal upset, nausea and vomiting, anorexia, constipation, headache, tremor, dizziness, weakness, visual problems, dry mouth, paresthesia, peripheral neuropathy, ataxia and memory loss.

### Hepatotoxicity

In placebo controlled trials, liver test abnormalities were no more common with miglustat than with placebo treatment, and what abnormalities occurred were mild and resolved spontaneously usually without need for dose interruption. During these premarketing clinical trials and since its more widespread clinical availability, no instances of acute liver injury with jaundice have been reported attributable to miglustat. However, the total clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which miglustat might cause serum aminotransferase elevations or liver injury is not known. Miglustat is extensively metabolized by the liver via the cytochrome P450 system (predominantly CYP 2D6 and 3A) and is susceptible to drug-drug interactions with agents that induce or inhibit these enzymes.

### Outcome and Management

The serum aminotransferase elevations that occur on miglustat therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of severe hepatitis, acute liver failure or vanishing bile duct syndrome due to miglustat have been reported.

Drug Class: Gaucher Disease Agents

Other Drugs in the Class: Eliglustat, Glucocerebrosidase (Enzyme Replacement Therapy)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Miglustat – Generic, Zavesca®

DRUG CLASS

Gaucher Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Miglustat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Miglustat | 72599-27-0 | C10-H21-N-O4 | Miglustat chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 March 2018

Pastores GM, Barnett NL, Kolodny EH. An open-label, noncomparative study of miglustat in type I Gaucher disease: efficacy and tolerability over 24 months of treatment. Clin Ther 2005; 27: 1215-27. (Among 10 adults with Gaucher disease treated with miglustat [100 mg thrice daily] for up to 2 years, liver and spleen size decreased, platelet counts rose and hemoglobin levels were stable; while common side effects were abdominal discomfort, diarrhea, flatulence, headache, tremor and paresthesia, there were no serious adverse events and no mention of ALT elevations or hepatotoxicity). 16199246
Patterson MC, Vecchio D, Prady H, Abel L, Wraith JE. Miglustat for treatment of Niemann-Pick C disease: a randomised controlled study. Lancet Neurol 2007; 6: 765-72. (Among 29 patients 12 years of age or older with Niemann-Pick C disease treated with miglustat or placebo for 12 months, miglustat was associated with improvements in eye movements and swallowing, and adverse events included diarrhea, weight loss, abdominal pain, headache, tremor, nausea, fatigue, insomnia and depression; no mention of ALT elevations or hepatotoxicity). 17689147
Schiffmann R, Fitzgibbon EJ, Harris C, DeVile C, Davies EH, Abel L, van Schaik IN, et al. Randomized, controlled trial of miglustat in Gaucher's disease type 3. Ann Neurol 2008; 64: 514-22. (Among 30 patients with Gaucher disease type 3 treated with miglustat or not, there were no differences in changes in spleen and liver size, and side effects were common including elevations in serum AST in 21% of patients, but no details provided regarding time of onset, duration and severity). 19067373
Hollak CE, Hughes D, van Schaik IN, Schwierin B, Bembi B. Miglustat (Zavesca) in type 1 Gaucher disease: 5-year results of a post-authorisation safety surveillance programme. Pharmacoepidemiol Drug Saf 2009; 18: 770-7. (A prospective surveillance program with information on 122 patients with type 1 Gaucher disease treated with miglustat for up to 5 years found side effects to include new neurological [19%], bone [9%] and gastrointestinal [3%] disturbances, but did not mention ALT elevations or new onset liver disease). 19507165
Shapiro BE, Pastores GM, Gianutsos J, Luzy C, Kolodny EH. Miglustat in late-onset Tay-Sachs disease: a 12-month, randomized, controlled clinical study with 24 months of extended treatment. Genet Med 2009; 11: 425-33. (Among 30 patients with late onset Tay-Sachs disease treated with miglustat [200 mg twice daily] or not for 24 months, there were no differences in changes in muscle strength and common adverse events were weight loss, diarrhea, dizziness and paresthesia; “no unexpected abnormal laboratory findings were detected”). 19346952
Patterson MC, Vecchio D, Jacklin E, Abel L, Chadha-Boreham H, Luzy C, Giorgino R, Wraith JE. Long-term miglustat therapy in children with Niemann-Pick disease type C. J Child Neurol 2010; 25: 300-5. (Among 10 children with Niemann-Pick disease type C who were continued on miglustat therapy for 24 months, common side effects were diarrhea, weight loss and tremor, while “there was no pattern of clinically significant abnormal laboratory findings” and mean ALT levels fell by -0.3 U/L). 19822772
Guffon N, Bin-Dorel S, Decullier E, Paillet C, Guitton J, Fouilhoux A. Evaluation of miglustat treatment in patients with type III mucopolysaccharidosis: a randomized, double-blind, placebo-controlled study. J Pediatr 2011; 159: 838-844. (Among 25 patients with type III mucopolysaccharidosis treated with miglustat or placebo for up to 12 months, there were no improvements in cognitive test results or motor skills with miglustat and rates of side effects [mostly gastrointestinal] were higher; no mention of ALT elevations or hepatotoxicity). 21658716
Cox TM, Amato D, Hollak CE, Luzy C, Silkey M, Giorgino R, Steiner RD; Miglustat Maintenance Study Group. Evaluation of miglustat as maintenance therapy after enzyme therapy in adults with stable type 1 Gaucher disease: a prospective, open-label non-inferiority study. Orphanet J Rare Dis 2012; 7: 102 (Among 42 patients with Gaucher disease on enzyme replacement therapy treated with miglustat for 2 years, liver volume did not change and side effects were common including diarrhea [71%], tremor [36%] and headache [21%]; no mention of results of laboratory test results). 23270487
Kuter DJ, Mehta A, Hollak CE, Giraldo P, Hughes D, Belmatoug N, Brand M, et al. Miglustat therapy in type 1 Gaucher disease: clinical and safety outcomes in a multicenter retrospective cohort study. Blood Cells Mol Dis 2013; 51: 116-24. (Among 115 patients with type 1 Gaucher disease treated with miglustat in clinical practice, 49 [43%] stopped treatment mostly because of adverse events; no mention of liver related adverse events or ALT elevations). 23683771
Chien YH, Peng SF, Yang CC, Lee NC, Tsai LK, Huang AC, Su SC, et al. Long-term efficacy of miglustat in paediatric patients with Niemann-Pick disease type C. J Inherit Metab Dis 2013; 36: 129-37. (Among 5 children with Niemann-Pick disease type C treated with miglustat for up to 6 years, most children had stable disease and “no safety and tolerability issues were reported”). 22476655
Patterson MC, Mengel E, Vanier MT, Schwierin B, Muller A, Cornelisse P, Pineda M; NPC Registry investigators. Stable or improved neurological manifestations during miglustat therapy in patients from the international disease registry for Niemann-Pick disease type C: an observational cohort study. Orphanet J Rare Dis 2015; 10: 65. (Among 92 European patients with Neimann-Pick disease type C treated with continuous miglustat and enrolled in an international registry, 70% were categorized as improved or stable and “no unexpected safety findings were identified” ). 26017010
Brand M, Muller A, Alsop J, van Schaik IN, Bembi B, Hughes D. Results from a 9-year Intensive Safety Surveillance Scheme (IS(3)) in miglustat (Zavesca(®))-treated patients. Pharmacoepidemiol Drug Saf 2015; 24: 329-33. (During 9 years of an intensive safety surveillance scheme which enrolled 407 patients [half with Gaucher disease] treated with miglustat for up to 9 years, 51% discontinued therapy, largely because of adverse events usually gastrointestinal [diarrhea, weight loss]; no mention of ALT elevations or hepatotoxicty]). 25656910
Eliglustat (Cerdelga)--an oral drug for Gaucher disease. Med Lett Drugs Ther 2015; 57 (1472): e100-1. (Concise review of the mechanism of action, clinical efficacy, safety, drug-drug interactions and costs of eliglustat [another oral glucosylceramide synthase inhibitor] shortly after its approval in the US; mentions side effects of fatigue, headache, nausea, diarrhea and back pain, but does not mention ALT elevations or hepatotoxicity). 26147895
Giraldo P, Andrade-Campos M, Alfonso P, Irun P, Atutxa K, Acedo A, Barez A, et al. Twelve years of experience with miglustat in the treatment of type 1 Gaucher disease: The Spanish ZAGAL project. Blood Cells Mol Dis 2016 Oct 24. [Epub ahead of print] (Among 63 Spanish patients with type 1 Gaucher disease treated enzyme replacement therapy and then switched to miglustat and followed for up to 10 years, blood counts, liver volume and spleen sizes remained stable, while side effects included transient diarrhea in 40%, mild temporary tremor in 60% and nonprogressive neuropathy in 3%; no mention of ALT elevations or hepatotoxicity). 27836529
Zimran A, Belmatoug N, Bembi B, Deegan P, Elstein D, Fernandez-Sasso D, Giraldo P, et al.; GOS Study group. Demographics and patient characteristics of 1209 patients with Gaucher disease: Descriptive analysis from the Gaucher Outcome Survey (GOS). Am J Hematol 2018; 93: 205-12. (Summary of clinical features of 1209 patients [95% type 1] enrolled in an international Gaucher disease registry between 2010 and 2017, including 887 [73%] who received at least one therapy, most commonly imiglucerase [66%], velaglucerase [57%], alglucerase [12%], taliglucerase [10%] and miglustat [10%], does not mention adverse events or liver related complications of treatment). 29090476

## OTHER REFERENCE LINKS

1. Recent References on Miglustat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Miglustat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Miglustat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Miglustat)